# Ginger

## OVERVIEW

### Introduction

Ginger (Zingiber officinale) is a commonly used spice and herbal medication that is made from the roots (tuberous rhizomes) of a creeping perennial plant native to Southeast Asia. As an herbal supplement, ginger is used predominantly for gastrointestinal upset, nausea, and vomiting. Ginger is generally recognized as safe (GRAS) and has not been linked to serum aminotransferase elevations nor to instances of clinically apparent liver injury.

### Background

Ginger (Zingiber officinale) is a food, spice, and traditional botanical medication that is made from the roots (rhizomes) of a creeping perennial plant native to Southeast Asia and that is used to treat gastrointestinal upset, nausea and vomiting, dyspepsia, as well as osteoarthritis, anxiety and agitation. Ginger is rich in volatile oils (2% to 3%) such as the aryl alkanes, gingerol, shogaols, gingerdiols and diarylheptanoids, which account for its scent and flavor as well as for its biologic activity. Ginger is 50% starch by weight and is a carbohydrate food source. In animal models, ginger extracts increase the flow of saliva, bile, and gastric secretions and increases peristalsis. It also inhibits serotonin and cyclooxygenase, suggesting that it might have activity in treating anxiety and depression as well as inflammatory conditions and pain. Ginger is not formally approved as therapy for any medical condition, but is used in over-the-counter dietary supplements for many conditions including gastrointestinal complaints such as nausea and vomiting, indigestion, psychological problems such anxiety and depression, inflammatory conditions such as arthritis, and metabolic disorders such as hyperlipidemia, diabetes and glucose control. Clinical trials have suggested that ginger may have some effect on the nausea and vomiting of pregnancy, and possibly for motion sickness and nausea and vomiting caused by cancer chemotherapy. There have been many clinical trials of ginger in various conditions, but the studies were often small and poorly controlled, and usually evaluated short courses of therapy and comparing ginger to placebo rather than other agents of proven benefit. The usual dose regimen of ginger varies greatly as does the concentration and purity of the product, some preparations being raw powdered extracts and others being semi purified components (usually gingerol and shogaols). The typical dose is up to the equivalent of 1000 mg of dried powdered extract daily. Ginger has been given in various forms and concentrations from one to three times daily. Ginger is generally recognized as safe (GRAS, by the FDA definition) and has few if any adverse side effects. Most frequently mentioned adverse events are mild and transient heartburn, bloating, dyspepsia, and diarrhea or constipation. In many clinical studies the rates of adverse events in ginger treated patients were similar to the rates in placebo recipients and less than in recipients of comparator agents. Ginger has been evaluated in pregnancy associated nausea and vomiting and has not been linked to fetal toxicity or teratogenesis. Hypersensitivity reactions have been reported but are rare and usually characterized as mild-to-moderate urticaria or rash. Anaphylaxis and Stevens Johnson syndrome have not been described with its use.

### Hepatotoxicity

Ginger has been extensively evaluated in many clinical trials for various conditions, but few studies included prospective monitoring of serum aminotransferase levels or other laboratory results. While ginger has not been linked to serum enzyme elevations during therapy, few studies in humans have included routine liver tests before and during treatment. Ginger is regularly described as well tolerated and often as without side effects. In more than 100 clinical trials of ginger, there were no reports of hepatotoxicity or clinically apparent liver injury. While ginger is a commonly used botanical, it does not appear in lists of herbs known to cause liver injury or reported to pharmacovigilance registries. A single case report from Japan described an elderly lady who developed acute hepatocellular injury with jaundice after having taken a commercial botanical product said to contain ginger for two months. She recovered rapidly after the product was stopped, but its purity, other constituents, and lack of contaminants were not characterized. Thus, ginger is an unlikely cause of acute liver injury but it has not been assessed carefully or thoroughly for the possibility.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: Indian ginger, Shoga, Zingiber officinale, Zingiberis, Zinziber officinale

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ginger – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Gingerol | 23513-14-6 | C17-H26-O | SID: 135049126
Shogaol | 555-66-8 | C17-H24-O3 | SID: 134976704

## ANNOTATED BIBLIOGRAPHY

References updated: 10 February 2024

Abbreviations: DSHEA, Dietary Supplement Health and Education Act; HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications linked to liver injury are discussed, but ginger is not mentioned).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbals does not mention ginger).
Ginger. PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007; pp. 365-70. (Compilation of short monographs on herbal medications and dietary supplements).
Phillips S, Ruggier R, Hutchinson SE. Zingiber officinale (ginger)—an antiemetic for day case surgery. Anaesthesia. 1993;48:715-7. (Among 120 patients undergoing outpatient laparoscopic gynecological surgery treated postoperatively with ginger [1 g], metoclopramide [10 mg], or placebo twice daily for 4 days, nausea and vomiting were similar between the two treatment arms and slightly lower than with placebo, while “side effects were very low and not different between groups”). 8214465
Schmid R, Schick T, Steffen R, Tschopp A, Wilk T. Comparison of seven commonly used agents for prophylaxis of seasickness. J Travel Med. 1994;1:203-206. (Among 1489 participants in a whale watch boat trip treated with one of 7 drugs to prevent seasickness, 203 were given ginger [250 mg], slight sickness occurred in 19-27% [ginger 22%] with vomiting in 4-10% [ginger 8%]; no mention adverse events). 9815340
Ernst E, Pittler MH. Efficacy of ginger for nausea and vomiting: a systematic review of randomized clinical trials. Br J Anaesth. 2000;84:367-71. (A systematic review of studies of prophylaxis with ginger against nausea and vomiting, found that ginger had a beneficial effect in most studies, but did not prevent all symptoms and some trials demonstrated no effect; no mention or discussion of adverse events). 10793599
Altman RD, Marcussen KC. Effects of a ginger extract on knee pain in patients with osteoarthritis. Arthritis Rheum. 2001;44:2531-8. (Among 247 adults with painful knee osteoarthritis treated with an herbal preparation with ginger [Zingiber officinalis] and a related ginger [Alpinia galanga] or placebo twice daily for 6 weeks, reduction in knee pain upon standing and after walking was greater with the ginger product as were adverse event rates [59% vs 37%], discontinuations for adverse events [13% vs 6%], and gastrointestinal side effects [45% vs 16%]; ALT levels were not monitored and there were no hepatic serious adverse events). 11710709
Vutyavanich T, Kraisarin T, Ruangsri R. Ginger for nausea and vomiting in pregnancy: randomized, double-masked, placebo-controlled trial. Obstet Gynecol. 2001;97:577-82. (Among 70 women with nausea and vomiting of pregnancy treated with ginger [1 g] or placebo once daily for 4 days, both nausea and vomiting episodes improved more with ginger, and side effects included only mild heartburn, abdominal discomfort and headache in one patient each; no serious adverse events or mention of hepatotoxicity). 11275030
Willetts KE, Ekangaki A, Eden JA. Effect of a ginger extract on pregnancy-induced nausea: a randomised controlled trial. Aust N Z J Obstet Gynaecol. 2003;43:139-44. (Among 120 pregnant women with daily morning sickness treated with either ginger [1.5 g] or placebo 4 times daily for 4 days, nausea symptom scores decreased in both groups, but more with ginger while vomiting scores did not differ, and adverse events of ginger leading to discontinuation included heartburn in 4, spontaneous abortion in 3, and an allergic reaction in one; ALT levels were not done). 14712970
Manusirivithaya S, Sripramote M, Tangjitgamol S, Sheanakul C, Leelahakorn S, Thavaramara T, Tangcharoenpanich K. Antiemetic effect of ginger in gynecologic oncology patients receiving cisplatin. Int J Gynecol Cancer. 2004;14:1063-9. (Among 48 women with gynecologic cancer receiving cisplatin based chemotherapy treated with either ginger root powder or metoclopramide for 5 days and crossed over during the next cycle, control of nausea and vomiting was no different with the two drug regimens, although side effects were less with ginger [19% vs 28%], restlessness in 5% vs 19%, constipation in 7% vs 14%, and diarrhea in 14% vs 5%; no mention of ALT elevations or hepatotoxicity). 15571611
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none were specifically attributed to a product containing ginger). 15390328
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. [Liver injury induced by "natural remedies": an analysis of cases submitted to the Spanish Liver Toxicity Registry]. Rev Esp Enferm Dig 2008; 100: 688-95. Spanish. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, but none were attributed to ginger). 19159172
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Review of the problems of causality assessment in herbal and dietary supplement [HDS] associated liver disease, including the variable clinical presentations, the complexity and lack of information on their components, absence of controlled trials demonstrating safety and efficacy, the possibility of contamination or incorrect labeling, and the frequent underreporting of herbal use by patients. Regulation of HDS is under DSHEA, which requires manufacturers to determine safety and prohibits claims of efficacy in treating specific diseases. The US Pharmacopeia sets standards for food and drugs and includes HDS; HDS induced liver injury is a growing problem and currently accounts for at least 10% of cases of acute liver injury due to medications). 19826971
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry; no mention of ginger). 19650152
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, but none were attributed to ginger). 20949552
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, but ginger was not listed or mentioned). 22928722
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to a product containing ginger). 25043597
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being green tea and none were attributed to ginger [see also Navarro et al Hepatology 2014]). 25754159
Suzuki Y, Yamazaki Y, Hashizume H, Oyama T, Horiguchi N, Sato K, Kakizaki S, et al. [Drug-induced liver injury caused by a dietary supplement (Kin-toki Shoga(®)) made from ginger]. Nihon Shokakibyo Gakkai Zasshi. 2015;112:108-14. Japanese. (70 year old woman developed abdominal pain and dark urine followed by jaundice two months after starting a supplement called Kin-toki Shoga ginger [bilirubin 10.8 mg/dL, ALT 2052 U/L, Alk P 784 U/L], liver biopsy showing an acute hepatitis and resolving over the 4 to 6 weeks after stopping). 25744927
McParlin C, O'Donnell A, Robson SC, Beyer F, Moloney E, Bryant A, Bradley J, et al. Treatments for hyperemesis gravidarum and nausea and vomiting in pregnancy: a systematic review. JAMA. 2016;316:1392-1401. (Systematic review including 17 randomized controlled trials of ginger for nausea and vomiting of pregnancy concluded that ginger had greater benefit than placebo and that side effects are generally mild, most frequently acid reflux). 27701665
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci 2016; 17: 537. (Listing of published cases of liver injury from HDS products, but does not mention or list ginger). 27070596
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107: 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements). 27818322
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not mention or list ginger). 27402097
Navarro VJ, Khan I, Björnsson E, Seeff LB, Serrano J, Hoofnagle JH. Liver injury from herbal and dietary supplements. Hepatology 2017; 65: 363-73. (Review of the problems of liver injury and HDS products, mentions that multiingredient dietary supplements account for the major of cases but does not mention a product with ginger as a component). 27677775
Bossi P, Cortinovis D, Fatigoni S, Cossu Rocca M, Fabi A, Seminara P, Ripamonti C, et al. A randomized, double-blind, placebo-controlled, multicenter study of a ginger extract in the management of chemotherapy-induced nausea and vomiting (CINV) in patients receiving high-dose cisplatin. Ann Oncol. 2017;28:2547-2551. (Among 251 adults undergoing chemotherapy for cancer with a cisplatin-based regimen treated with a purified extract of ginger [40 mg] or placebo twice daily for 4 days, nausea and vomiting symptom scores did not differ in the two groups and adverse event rates were similar and largely unrelated to therapy). 28666335
Anh NH, Kim SJ, Long NP, Min JE, Yoon YC, Lee EG, Kim M, Kim TJ, et al. Ginger on human health: a comprehensive systematic review of 109 randomized controlled trials. Nutrients. 2020;12:157. (An extensive systematic review of clinical trials of ginger for various conditions identified 109 qualifying trials including 43 considered to be of high quality, providing convincing data of the benefit of ginger for nausea and vomiting of pregnancy, inflammation [including osteoarthritis], metabolic function [hyperlipidemia, glucose control], digestive function, and colorectal cancer markers, whereas the beneficial effects of ginger in other conditions studied were “relatively controversial”, but adverse events are mostly mild gastrointestinal complaints; no mention of serious adverse events or hepatoxicity). 31935866
Martins LB, Rodrigues AMDS, Monteze NM, Tibaes JRB, Amaral MHA, Gomez RS, Teixeira AL, et al. A double-blind placebo-controlled randomized clinical trial of ginger (Zingiber officinale Rosc.) in the prophylactic treatment of migraine. Cephalalgia. 2020;40:88-95. (Among 107 adults with episodic migraine treated with ginger [200 mg] or placebo 3 times daily for 3 months, there was no difference in rate of migraine episodes in the two groups, but adverse events were more frequent with ginger including heartburn in 12 [23%] that led to early discontinuation in 4 [7.5%], no mention of ALT elevations or hepatoxicity). 31398997
Nocerino R, Cecere G, Micillo M, De Marco G, Ferri P, Russo M, Bedogni G, et al. Efficacy of ginger as antiemetic in children with acute gastroenteritis: a randomised controlled trial. Aliment Pharmacol Ther. 2021;54:24-31. (Among 150 children with acute gastroenteritis treated with ginger extract [10 mg in 20 liquid drops, repeated every 8 hours until vomiting stops] vs placebo, episodes of vomiting occurred in 67% vs 87% in the subsequent two days and there were no adverse events reported from either group). 34018223
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; ginger was not among the 79 implicated products). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while ginger is not mentioned). 33434654
Samadi M, Moradinazar M, Khosravy T, Soleimani D, Jahangiri P, Kamari N. A systematic review and meta-analysis of preclinical and clinical studies on the efficacy of ginger for the treatment of fatty liver disease. Phytother Res. 2022;36:1182-1193. (Review of the literature on efficacy of ginger in nonalcoholic fatty liver disease in animal models and in 3 human studies suggested that therapy with ginger reduced serum ALT by 3 U/L, AST by 1 U/L, cholesterol by 3.5 mg/dL, triglycerides by 5 mg/dl and fasting blood sugar by 2.5 mg/dL; no mention of adverse events). 35106852
Choi J, Lee J, Kim K, Choi HK, Lee SA, Lee HJ. Effects of ginger intake on chemotherapy-induced nausea and vomiting: a systematic review of randomized clinical Trials. Nutrients. 2022;14:4982. (Systematic review of 23 randomized controlled trials found no evidence for a benefit effects of therapy with ginger in preventing early or delayed nausea or vomiting and while 9 studies reported no adverse events, 7 studies reported adverse event rates that were similar to those in placebo recipients, the most common being gastrointestinal symptoms; no mention of ALT elevation or hepatotoxicity). 36501010
Sarecka-Hujar B, Szulc-Musioł B. Herbal medicines-are they effective and safe during pregnancy? Pharmaceutics. 2022;14:171. (Literature review of the safety and efficacy of selected herbal therapies [cranberry, chamomile, Echinacea, garlic, ginkgo, peppermint, and ginger] concludes that data on safety are somewhat sparse for most agents, but data fairly strongly indicate that doses of ginger 1000 mg/kg or less in animals and 1000 mg or less in humans have no adverse effects on pregnancy or fetal health and development). 35057067
Afshar F, Abdolahi N, Amin G, Esmaily H, Ziayie S, Azimi S, Darvishi B, et al. A randomized, double-blind placebo-controlled phase I clinical study on safety and efficacy of the G-Rup® syrup (a mixture of ginger extract and honey) in symptomatic treatment of knee osteoarthritis. J Clin Pharm Ther. 2022;47:2295-2301. (Among 44 adults with osteoarthritis of the knee treated with a commercial syrup containing ginger and honey or placebo twice daily for 12 weeks, symptom scores for pain, stiffness, and function improved more with the ginger syrup than placebo and adverse event rates were similar in the two groups; no mention of hepatotoxicity). 36453014
Mahawer SK, Kumar R, Prakash O, Arya S, Singh S, de Oliveira MS, Rawat DS. A comprehensive review on phytochemistry, ethnopharmacology, and pharmacological properties of Zingiber roseum (Roxb.) Roscoe. Curr Top Med Chem. 2023;23:931-942. (Review of the phytochemistry, traditional uses, pharmacology, and biologic activities of ginger). 36703584

## OTHER REFERENCE LINKS

Recent References on Ginger: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ginger+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Ginger: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ginger)